# Atogepant

## OVERVIEW

### Introduction

Atogepant is a small molecule inhibitor of the calcitonin gene-related peptide (CGRP) receptor that blocks the action of CGRP, a potent vasodilator believed to play a role in migraine headaches. Atogepant is approved for prevention of acute migraine attacks. In clinical trials, atogepant was generally well tolerated with only rare instances of transient serum aminotransferase elevations during therapy and with no reported instances of clinically apparent liver injury.

### Background

Atogepant (a toe’ je pant) is a small molecule inhibitor of the receptor for the calcitonin gene-related peptide (CGRP), which is believed to play a role in the pathogenesis of migraine headaches. CGRP is a potent vasodilator and pain-signaling neurotransmitter that is found throughout the central and peripheral nervous system but is particularly common in trigeminal ganglia. Levels of CGRP in the blood are elevated during episodes of migraine headache, and administration of the peptide can induce migraines in susceptible patients. For this reason, approaches to inhibition of CGRP signaling were developed as potential therapies for migraine, both as preventive therapies to decrease the frequency of migraine attacks, as well as for treatment of acute attacks. Several monoclonal antibodies that block CGRP or its receptor are approved for use in prevention of migraines, and several other small molecule inhibitors of the CGRP receptor (the “gepants”: rimegepant and ubrogepant) are available for treatment of acute migraine. In several randomized, placebo-controlled trials, atogepant in oral doses of 10, 30 or 60 mg daily was found to decrease the number of migraine days per month by 0.7 to 1.7 migraine days per month. Atogepant was approved for prevention of acute migraine in the United States in 2021 and is available in tablets of 10, 30, and 60 mg under the brand name Qulipta. The recommended dose is 10, 30, or 60 mg daily depending upon response, tolerance, and the pattern of migraines experienced (episodic vs chronic). Atogepant is generally well tolerated with side effects of nausea, dizziness, somnolence, and constipation, that are generally uncommon (<5%), transient and mild-to-moderate in severity. Severe adverse events can include hypersensitivity reactions, including anaphylaxis and dyspnea, which can occur days after administration.

### Hepatotoxicity

In preregistration, controlled trials of atogepant in several thousand patients, mild-to-moderate serum aminotransferase elevations arose in a small percentage of patients (1% to 2%) and overall rates were not different from those in placebo recipients (1.0% vs 1.8%). In the controlled trials and subsequently with general use, there have been no reports of clinically apparent liver injury attributed to atogepant. In contrast, telcagepant, the initial oral CGRP receptor antagonist evaluated as therapy for migraine headaches, was abandoned during development because of several instances of clinically apparent liver injury in recipients that was characterized by marked elevations in serum aminotransferase levels and symptoms of fatigue, nausea and abdominal discomfort arising within 2 to 4 weeks of starting therapy. These symptoms rapidly resolved after prompt stopping of therapy. Similar episodes have not been reported with atogepant. Careful analysis of all cases of ALT or AST elevations in atogepant treated subjects demonstrated 6 instances that were considered possibly or probably due to drug treatment, but all were asymptomatic, anicteric, and self-limited in course once atogepant was stopped.

Likelihood score: E* (unproven but possibly rate cause of clinically apparent acute liver injury).

### Mechanism of Injury

Possible mechanisms of liver injury due to atogepant are not known. It is metabolized in the liver largely by CYP 3A4 and is susceptible to drug-drug interactions with agents that induce or inhibit this microsomal enzyme. Lower doses should be used in patients receiving CYP 3A4 inhibitors.

### Outcome and Management

Drug Class: Migraine Headache Agents

Other Small Molecule Inhibitors of CGRP Receptors: Rimegepant, Ubrogepant, Zavegepant

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Atogepant – Qulipta®

DRUG CLASS

Migraine Headache Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Atogepant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Atogepant | 1374248-81-3 | C29-H23-F6-N5-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 12 January 2025

Abbreviations: CGRP, calcitonin gene-related peptide.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of CGRP antagonists).
FDA. Integrated Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/215206Orig1s000IntegratedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA integrated scientific review of the atogepant application including specific discussion of hepatic adverse events among 1319 patients treated with atogepant focusing on 2 instances of ALT or AST elevations considered “probable” and 4 “possible” liver injury, despite similar rate elevations above 3 times ULN between drug vs placebo groups [1.0% vs 1.8%]; all suspected cases were asymptomatic, without bilirubin elevations, and resolving rapidly once drug was stopped).
Ho TW, Connor KM, Zhang Y, Pearlman E, Koppenhaver J, Fan X, Lines C, et al. Randomized controlled trial of the CGRP receptor antagonist telcagepant for migraine prevention. Neurology 2014; 83: 958-66. (Among 660 patients with migraine enrolled in a controlled trial of telcagepant [140 or 280 mg] vs placebo twice daily for 12 weeks, 13 patients on telcagepant developed ALT elevations above 3 times ULN, generally between weeks 4 and 6 of treatment, and in two instances rising to 33 and 39 times ULN accompanied by symptoms but not jaundice leading to prompt discontinuation and to early termination of the trial because of the risk of significant hepatotoxicity). 25107879
Tfelt-Hansen P, Loder E. The emperor's new gepants: are the effects of the new oral CGRP antagonists clinically meaningful? Headache 2019; 59: 113-7. (Commentary on the relative efficacy of two oral CGRP receptor antagonists, ubrogepant and rimegepant, which show only modest efficacy in acute migraine [therapeutic gain of 5-8%] and only when compared to placebo as compared to well-known effective therapies such as aspirin and other nonsteroidal antiinflammatory agents [8-14%] and the triptans [16-32%]). 30451300
Drugs for migraine. Med Lett Drugs Ther 2020; 62: 153-60. (Concise summary of the relative clinical efficacy, safety, and costs of drugs to treat acute migraine headache [such as analgesics, opiates, triptans, ergots and oral CGRP receptor antagonists] and to prevent migraines [such as anticonvulsants, beta blockers, antidepressants, and the monoclonal antibodies to CGRP and its receptor]). 33434187
Goadsby PJ, Dodick DW, Ailani J, Trugman JM, Finnegan M, Lu K, Szegedi A. Safety, tolerability, and efficacy of orally administered atogepant for the prevention of episodic migraine in adults: a double-blind, randomised phase 2b/3 trial. Lancet Neurol. 2020;19:727-737. (Among 825 adults with chronic migraine headaches treated with 5 doses of atogepant [10, 30, or 60 mg once or twice daily] vs placebo, reduction in migraine days per month was similar across all dose regimens [-3.8 to -4.1] and higher than with placebo [-2.9], while adverse event rates with slightly higher [58 to 66% vs 49%] and ALT elevations above 3 times ULN were uncommon and similar in rate to those with placebo [1 to 2% vs 1%], and were all without symptoms or jaundice). 32822633
Min KC, Kraft WK, Bondiskey P, Colón-González F, Liu W, Xu J, Panebianco D, et al. Atogepant Is not associated with clinically meaningful alanine aminotransferase elevations in healthy adults. Clin Transl Sci. 2021;14:599-605. (Among 34 healthy adults treated with atogepant [170 mg] or placebo once daily for 28 days, adverse events in atogepant treated subjects were mild and included nausea, fatigue, dizziness and decreased appetite, while mean ALT levels decreased and remained within the normal range with no individual value rising about 3 times ULN). 33142014
Ailani J, Lipton RB, Goadsby PJ, Guo H, Miceli R, Severt L, Finnegan M, Trugman JM; ADVANCE Study Group. Atogepant for the preventive treatment of migraine. N Engl J Med. 2021;385:695-706. (Among 873 adults with episodic migraine headaches treated with atogepant [10, 30, or 60 mg] or placebo once daily for 12 weeks, mean difference from placebo with atogepant ranged from -1.2 to -1.7 days per month, while adverse events rates were similar with ALT elevations above 3 times ULN being lower with atogepant [0.4 to 0.9%] vs placebo [2.7%], no ALT elevation being associated with jaundice). 34407343
Atogepant (Qulipta) for migraine prevention. Med Lett Drugs Ther. 2021;63:169-171. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of atogepant discusses minor adverse events of nausea, constipation, and fatigue but does not mention ALT elevations or hepatoxicity). 35085204
Robbins MS. Diagnosis and management of headache: a review. JAMA 2021; 325: 1874-85. (Review of the diagnosis and management of headache including use of calcitonin gene-related peptide antagonists for acute migraine attacks, which have uncommon side effects of dry mouth and dizziness; no mention of ALT elevations or hepatotoxicity). 33974014
Deeks ED. Atogepant: First approval. Drugs. 2022;82:65-70. (Summary of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of atogepant shortly after its approval for prevention of episodic migraine mentions that rates of ALT elevations above 3 times ULN were less frequent with atogepant than placebo [1.0 vs 1.8% in short term and 2.4 vs 3.2% in longer term studies], and no patient with ALT elevations developed symptoms or jaundice and abnormalities resolved rapidly with discontinuation). 34813050
Woodhead JL, Siler SQ, Howell BA, Watkins PB, Conway C. Comparing the liver safety profiles of 4 next-generation CGRP receptor antagonists to the hepatotoxic CGRP inhibitor telcagepant using quantitative systems toxicology modeling. Toxicol Sci. 2022;188:108-116. (Mechanism simulation of hepatotoxicity indicated that telcagepant had multiple potential adverse effects on liver function compared to the more recently developed CGRP antagonists, rimegepant, ubrogepant, atogepant, and zavegepant). 35556143
Drugs for migraine. Med Lett Drugs Ther. 2023;65:89-96. (Concise summary of the relative clinical efficacy, safety, and costs of drugs to treat and to prevent migraine headaches, states that systemic adverse effects are uncommon with use of oral CGRP receptor antagonists, but that nausea and somnolence can occur; no mention of ALT elevations or hepatotoxicity). 37266987
Zavegepant (Zavzpret) for acute treatment of migraine. Med Lett Drugs Ther. 2023;65:116-118. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of zavegepant mentions adverse events of dysgeusia, nausea, nasal discomfort, and vomiting as well as hypersensitivity reactions [facial swelling, urticaria], but does not mention ALT elevations or hepatoxicity). 37460143
Pozo-Rosich P, Ailani J, Ashina M, Goadsby PJ, Lipton RB, Reuter U, Guo H, et al. Atogepant for the preventive treatment of chronic migraine (PROGRESS): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet. 2023;402(10404):775-785. (Among 755 adults with chronic migraine treated with atogepant [30 mg twice or 60 mg once daily] vs placebo for 12 weeks, reduction of days with migraine headaches was greater with drug [-7.5 and -6.9 vs -5.1 days per month] and adverse events were generally mild and included constipation, nausea, fatigue, and weight loss, while ALT or AST elevations above 3 times ULN arose in 0.8% on atogepant vs 0.4% on placebo and no patient had concurrent symptoms or jaundice). 37516125
Tassorelli C, Nagy K, Pozo-Rosich P, Lanteri-Minet M, Sacco S, Nežádal T, Guo H, et al. Safety and efficacy of atogepant for the preventive treatment of episodic migraine in adults for whom conventional oral preventive treatments have failed (ELEVATE): a randomised, placebo-controlled, phase 3b trial. Lancet Neurol. 2024;23:382-392. (Among 315 adults with refractory, episodic migraines treated with atogepant [60 mg] or placebo once daily for 12 weeks, the mean decrease in migraine days per month decreased more with drug [-4.1] than placebo [-1.9], while adverse events of atogepant included constipation [10%], nausea [7%], and decreased appetite [3%], but no patient developed ALT or AST elevations above 3 times ULN or any elevation with jaundice). 38364831
Liang Q, Liao X, Wu H, Huang Y, Liang T, Li H. Real-world study of adverse events associated with gepant use in migraine treatment based on the VigiAccess and U.S. Food and Drug Administration's adverse event reporting system databases. Front Pharmacol. 2024;15:1431562. (Search of two large registry databases on spontaneous reports of adverse events due to -gepants [rimegepant, ubrogepant, and atogepant] identified 23,542 reports, but only 0.09% to 0.27% were liver related, attesting to the lack of severe liver injury due to the currently available oral CGRP receptor antagonists). 39144633
Zhang Y, Sun S, Wang Y. Adverse events associated with atogepant: a FAERS-based pharmacovigilance analysis. Expert Opin Drug Saf. 2024 Sep 12:1-7. Epub ahead of print. (Search of atogepant adverse event reports made to the FDA’s Adverse Event Reporting System [FAERS] from 2021 through 2023, identified 3015 reports involving 27 body systems, most commonly neurologic [1651], general [1282], and gastrointestinal [1003], but very few related to hepatobiliary disorders [8]). 39242080

## OTHER REFERENCE LINKS

1. Recent References on Atogepant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Atogepant+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Atogepant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Atogepant)